# Brivaracetam

## OVERVIEW

### Introduction

Brivaracetam is a relatively unique anticonvulsant that is typically used in combination with other antiepileptic medications for partial onset seizures. Brivaracetam has been linked to rare instances of serum aminotransferase and alkaline phosphatase elevations during treatment and is suspected of causing rare cases of clinically apparent drug induced liver disease.

### Background

Brivaracetam (briv" a ra' se tam) is a pyrrolidine derivative related in structure to levetiracetam. Its mechanism of action is not known, but it, like levetiracetam, binds to the synaptic vesicle protein 2A (SV2A) in the brain and appears to act by preventing secondary spread of focal seizure activity and decreasing simultaneous neuronal firing. Brivaracetam was approved for use in epilepsy in 2016 and current indications are as adjunctive therapy for partial onset seizures in adults and in children 16 years or older. Brivaracetam is available as tablets of 10, 25, 50, 75 and 100 mg under the brand name Briviact. Liquid oral and injectable forms are also available. The recommended initial dose in adults is 50 mg twice daily, with dose adjustment based upon tolerance and effect downward or upward to a maximum of 100 mg twice daily. Common side effects include dizziness, somnolence, fatigue, and nausea and vomiting.

### Hepatotoxicity

Prospective studies reported that chronic brivaracetam therapy was not accompanied by significant elevations in serum aminotransferase levels and clinically apparent liver injury was not observed. Brivaracetam has had limited general use, but has not been linked to instances of clinically apparent liver injury. Levetiracetam, an anticonvulsant with similar structure and mechanism of action, has been linked to rare instances of acute liver injury, generally arising within 1 to 20 weeks and presenting with a hepatocellular pattern of injury without immunoallergic or autoimmune features. Whether similar cases will be linked to brivaracetam is not known.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which brivaracetam might cause liver injury is unknown, but is likely to be hypersensitivity. Brivaracetam is metabolized by hydrolysis followed by hydroxylation that is mediated by the cytochrome P450 system, predominantly CYP 2C19. Inhibitors of CYP 2C19 (such as carbamazepine and phenytoin) may increase and CYP 2C19 inducers (such as rifampin) may decrease brivaracetam levels.

### Outcome and Management

Minor serum enzyme elevations during brivaracetam therapy rarely require dose modification or discontinuation, but elevations above 5 times the ULN should lead to dose modification and search for other possible causes. Acute liver failure, chronic hepatitis and vanishing bile duct syndrome have not been reported with brivaracetam therapy, nor has anticonvulsant hypersensitivity (DRESS) syndrome, and brivaracetam may be a reasonable alternative in patients who have developed liver injury due to an aromatic anticonvulsant such as phenytoin, carbamazepine or lamotrigine.

Drug Class: Anticonvulsants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Brivaracetam – Briviact®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=brivaracetam)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Brivaracetam | 357336-20-0 | C11-H20-N2-O2 | Chemical Structure for Brivaracetam
Levetiracetam | 102767-28-2 | C8-H14-N2-O2 | Levetiraceta chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 02 October 2017

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999, before the availability of brivaracetam).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-41. (Review of anticonvulsant induced liver injury published in 2013; brivaracetam is not mentioned).
McNamara JO. Pharmacology of the epilepsies. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 583-608. (Textbook of pharmacology and therapeutics).
Knowles SR, Shapiro LE, Shear NH. Anticonvulsant hypersensitivity syndrome: incidence, prevention and management. Drug Saf 1999; 21: 489-501. (Review of anticonvulsant hypersensitivity syndrome: triad of fever, rash and internal organ injury occurring 1-8 weeks after exposure to anticonvulsant, liver being most common internal organ involved. Occurs in 1:1000-1:10,000 initial exposures to phenytoin, carbamazepine, phenobarbital or lamotrigine, unrelated to dose, perhaps predisposed by valproate; liver injury arises 1-4 weeks after onset of rash and ranges in severity from asymptomatic ALT elevations to icteric hepatitis to acute liver failure. High mortality rate with jaundice; other organs involved include muscle, kidney, brain, heart and lung. Pseudolymphoma syndrome and serum sickness like syndrome are separate complications of anticonvulsants. Role of corticosteroids is uncertain; cross reactivity among the agents should be assumed). 10612272
Hamer HM, Morris HH. Hypersensitivity syndrome to antiepileptic drugs: a review including new anticonvulsants. Clevel Clin J Med 1999; 66: 239-45. (Clinical review of anticonvulsant hypersensitivity syndrome which occurs in 1-5/10,000 users with higher risk in African Americans and affected siblings; liver involvement is common, but most cases are anicteric; other manifestations include facial edema, lymphadenopathy, bone marrow aplasia, pseudolymphoma, thyroiditis, interstitial nephritis; switching to valproate and benzodiazepines is safe, levetiracetam or brivaracetam might be other options). 10199060
Tan TC, de Boer BW, Mitchell A, Delriviere L, Adams LA, Jeffrey GP, Macquillan G. Levetiracetam as a possible cause of fulminant liver failure. Neurology 2008; 71: 685-6. (Patient developed acute liver failure 1 month after being switched from oxcarbazepine to levetiracetam [bilirubin 34.6 mg/dL, ALT 1610 U/L, Alk P 246 U/L], which recurred on restarting levetiracetam post liver transplant [bilirubin rising to 4.5 mg/dL, ALT 350 U/L, Alk P 650 U/L], resolving within 2 weeks of stopping). 18725594
Björnsson E. Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scan 2008; 118: 281-90. (Review of the hepatotoxicity of anticonvulsants; before the availability of brivaracetam).18341684
von Rosenstiel P. Brivaracetam (UCB 34714). Neurotherapeutics 2007; 4: 84-7. (Summary of pharmacology and efficacy of brivaracetam in preclinical studies of animal models of epilepsy, mentions that it is a derivative of levetiracetam with enhanced SV2A binding in parallel with enhanced in vitro antiepileptic activity). 17199019
French JA, Costantini C, Brodsky A, von Rosenstiel P; N01193 Study Group. Adjunctive brivaracetam for refractory partial-onset seizures: a randomized, controlled trial. Neurology 2010; 75: 519-25. (Among 208 adults with refractory partial seizures treated with brivaracetam [5, 20 or 50 mg daily] or placebo for 7 weeks, there was a dose related decline in seizure frequency, but little difference in adverse events and “no clinically significant changes” in blood chemistry results). 20592253
Gómez-Zorrilla S, Ferraz AV, Pedrós C, Lemus M, Peña C. Levetiracetam-induced drug reaction with eosinophilia and systemic symptoms syndrome. Ann Pharmacother 2012; 46: e20. (31 year old man with brain tumor developed fever, rash and interstitial pneumonitis 49 days after starting levetiracetam, improving with dexamethasone therapy, but recurring [ALT 60 U/L] and resolving only after stopping levetiracetam and switching to phenytoin). 22764327
Drugs for epilepsy. Treat Guidel Med Lett 2013; 11: 9-18. (Concise review of the efficacy and safety of drugs used to treat epilepsy; states that levetiracetam can cause Stevens Johnson syndrome and toxic epidermal necrolysis, but liver adverse events were not mentioned). 23348233
Van Paesschen W, Hirsch E, Johnson M, Falter U, von Rosenstiel P. Efficacy and tolerability of adjunctive brivaracetam in adults with uncontrolled partial-onset seizures: a phase IIb, randomized, controlled trial. Epilepsia 2013; 54: 89-97. (Among 157 patients with poorly controlled partial onset seizures treated with brivaracetam [50 or 150 mg daily] or placebo for 10 weeks, seizure frequency declined in both active treatment groups and common side effects were headache, fatigue, nasal stuffiness, nausea, somnolence and dizziness, but there were no drug related serious adverse events and no “clinically relevant” changes in laboratory test results). 22813235
Kwan P, Trinka E, Van Paesschen W, Rektor I, Johnson ME, Lu S. Adjunctive brivaracetam for uncontrolled focal and generalized epilepsies: results of a phase III, double-blind, randomized, placebo-controlled, flexible-dose trial. Epilepsia 2014; 55: 38-46. (Among 480 patients with poorly controlled focal and generalized seizures treated with brivaracetam [20 to 150 mg daily] or placebo for 16 weeks, seizure frequency declined with brivaracetam, and adverse event rates were similar and there were no liver related serious adverse events). 24116853
Ryvlin P, Werhahn KJ, Blaszczyk B, Johnson ME, Lu S. Adjunctive brivaracetam in adults with uncontrolled focal epilepsy: results from a double-blind, randomized, placebo-controlled trial. Epilepsia 2014; 55: 47-56. (Among 398 patients with focal seizures treated with one of 3 doses of brivaracetam or placebo for 12 weeks, seizure frequency declined with active treatment [by 27-33% vs 17% with placebo]; frequent side effects were headache, fatigue and somnolence, but there were no significant changes from baseline in mean blood chemistry results). 24256083
Biton V, Berkovic SF, Abou-Khalil B, Sperling MR, Johnson ME, Lu S. Brivaracetam as adjunctive treatment for uncontrolled partial epilepsy in adults: a phase III randomized, double-blind, placebo-controlled trial. Epilepsia 2014; 55: 57-66. (Among 396 patients with partial epilepsy treated with one of 3 doses of brivaracetam or placebo, seizure frequency was reduced with the highest doses and overall there were no clinically significant changes in blood chemistry results). 24446953
Klein P, Schiemann J, Sperling MR, Whitesides J, Liang W, Stalvey T, Brandt C, Kwan P. A randomized, double-blind, placebo-controlled, multicenter, parallel-group study to evaluate the efficacy and safety of adjunctive brivaracetam in adult patients with uncontrolled partial-onset seizures. Epilepsia 2015; 56: 1890-8. (Among 760 patients with poorly controlled partial onset seizures who were treated with brivaracetam [100 or 200 mg daily] or placebo for 12 weeks, the most common adverse events were somnolence, dizziness and fatigue and there were no changes from baseline in “blood chemistry parameters”). 26471380
Toledo M, Whitesides J, Schiemann J, Johnson ME, Eckhardt K, McDonough B, Borghs S, et al. Safety, tolerability, and seizure control during long-term treatment with adjunctive brivaracetam for partial-onset seizures. Epilepsia 2016; 57: 1139-51. (A pooled analysis of 12 studies of brivaracetam [50 to 200 mg daily] vs placebo found that the most frequent adverse events were headaches [21%], dizziness [17.5%], somnolence [15%] and fatigue [11%], and there were no hepatic serious adverse events or causes for drug discontinuation; results of laboratory tests “did not reveal any issues of clinical concern”). 27265725
Ben-Menachem E, Mameniškienė R, Quarato PP, Klein P, Gamage J, Schiemann J, Johnson ME, et al. Efficacy and safety of brivaracetam for partial-onset seizures in 3 pooled clinical studies. Neurology 2016; 87: 314-23. (In a pooled analysis of 3 clinical trials of brivaracetam [50, 100 or 200 mg daily] or placebo involving 1262 patients with partial onset seizures, adverse events were comparable in incidence between drug vs placebo treatment with somnolence in 15% vs 8.5%, fatigue in 9% vs 4%, and ”no clinically meaningful changes from baseline in clinical chemistry” results). 27335114
Brivaracetam (Briviact) for epilepsy. Med Lett Drugs Ther 2016; 58 (1499): 95-6. (Concise review of the mechanism of action, clinical efficacy, safety and costs of brivaracetam shortly after its approval for use in the US, mentions side effects of somnolence, sedation, dizziness, fatigue, nausea and vomiting, but does not mention ALT elevations or heptotoxicity). 27403785
Steinig I, von Podewils F, Möddel G, Bauer S, Klein KM, Paule E, Reif PS, et al. Postmarketing experience with brivaracetam in the treatment of epilepsies: A multicenter cohort study from Germany. Epilepsia 2017; 58: 1208-16. (Among 262 patients with epilepsy treated with brivaracetam for at least 3 months, common adverse events were somnolence, dizziness and behavioral changes; ALT elevations occurred in 7 patients [2.7%] but all were transient, less than 3 times ULN and not associated with symptoms or jaundice). 28480518

## OTHER REFERENCE LINKS

1. Recent References on Brivaracetam: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Brivaracetam/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Brivaracetam: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Brivaracetam)